# Somapacitan

## OVERVIEW

### Introduction

Somapacitan is a long acting, recombinant growth hormone analog that is used to treat adults and children two years of age or older with growth hormone deficiency. Somapacitan has not been linked to elevations in serum aminotransferase levels or bilirubin levels during therapy or to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Somapacitan (soe” ma pas’ i tan) is a long acting, recombinant form of human growth hormone that is used to treat both adults and children with growth hormone deficiency. Human growth hormone (GH) is a 191-amino acid polypeptide produced by the pituitary gland that has widespread effects on many organs and tissues either directly via growth hormone receptors or indirectly via production of insulin like growth factor-1 (IGF-1) by the liver. Deficiency in growth hormone is associated with short stature and abnormalities in body composition and metabolic factors. Replacement with recombinant human growth factor preparations can correct these abnormalities, increasing linear growth in children as well as increasing muscle and bone growth and decreasing fat mass. Somapacitan differs from typical recombinant human growth factor (somatotropin) in being administered weekly rather than daily by subcutaneous injection. Somapacitan is a slightly modified analog with amino acid 109 being changed to a cysteine with a long side chain with an albumin binding receptor. In the circulation, somapacitan binds to albumin which prolongs its half-life allowing for once weekly administration. In a registration randomized controlled trial in adults, somapacitan led to increases in serum IGF-1 levels, increases in lean body mass, and reduction in total body fat percentage, thus correcting abnormalities in body composition associated with growth hormone deficiency. In pediatric trials, somapacitan led to improvements in growth and physical development compatible with correction of growth hormone deficiency. For both children and adults, changes in body composition with somapacitan therapy were similar to those achieved with FDA approved recombinant growth hormone products that required daily administration. Somapacitan was approved in the United States in 2020 for treatment of adults with growth hormone deficiency. In 2023, the indications were extended to children 2.5 years of age or older with growth failure due to inadequate endogenous growth hormone secretion. Somapacitan is available in solution in self-injection pens of 5, 10, or 15 mg in 1.5 mL of normal saline under the brand name Sogroya. Somapacitan is administered subcutaneously once weekly. The recommended dose is based upon age and body weight and is titrated up from an initial low dose based upon clinical response, IGF-1 levels, and patient tolerance. Somapacitan therapy should be prescribed and supervised by a physician who is experienced in the diagnosis and management of growth hormone deficiency. Common side effects include back pain, arthralgia, dyspepsia, sleep disorder, dizziness, peripheral edema, nausea and vomiting, systemic arterial hypertension, weight gain, and anemia. Rare potentially severe adverse effects may include increased risk of malignancy, glucose intolerance and diabetes, intracranial hypertension, hypersensitivity reactions, marked fluid retention, hypoadrenalism, hypothyroidism, pancreatitis, and lipohypertrophy or lipoatrophy at the sites of administration.

Somapacitan is a long acting recombinant human growth hormone analog. Other FDA approved therapies of growth hormone deficiency include recombinant growth hormone products (somatotropins) that are administered daily. Switching daily therapy to weekly injections of somapacitan can be done but requires careful titration and individualization of the weekly doses.

### Hepatotoxicity

In preregistration trials, discussion of adverse events rarely mentioned serum aminotransferase elevations and did not report instances of clinically apparent liver injury. Somapacitan has been usually described as well tolerated with only mild or moderate adverse events, the majority of which were considered unrelated to treatment and occurred at similar rates in placebo recipients or subjects treated with recombinant growth hormone products requiring daily injections. Since its licensure and more widescale clinical use, there have been no published reports of acute liver injury attributed to somapacitan.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Liver test abnormalities are rare during somapacitan therapy and are generally considered unrelated to the recombinant protein. The lack of liver injury during somapacitan therapy is probably because it is metabolized by tissue proteases to short polypeptides or amino acids and does not interact with hepatic cytochrome P450 enzymes.

### Outcome and Management

The product label for somapacitan does not recommend monitoring of routine liver tests during therapy. A rise in serum aminotransferase levels or bilirubin during therapy should trigger evaluation for other possible causes.

Drug Class: Growth Hormone Deficiency Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Somapacitan – Sogroya®

DRUG CLASS

Human Growth Hormone Deficiency Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Somapacitan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Somapacitan | 1338578-34-9 | C54-H95-N13-O20-S2

## BIBLIOGRAPHY

References updated: 01 July 2024

Abbreviations: IGF-1, insulin like growth factor-1; ULN, upper limit of the normal range.

FDA. Clinical Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761156Orig1s000MedR.pdf (Summary of the data the safety and efficacy of somapacitan submitted in support of its approval as therapy of growth hormone deficiency, makes no specific mention of serum aminotransferase or bilirubin elevations, and after discussion of IGF-1 and glucose levels during treatment states “no other clinically relevant changes in other biochemistry parameters were observed”).
Johannsson G, Feldt-Rasmussen U, Håkonsson IH, Biering H, Rodien P, Tahara S, Toogood A, et al.; REAL 2 Study Group. Safety and convenience of once-weekly somapacitan in adult GH deficiency: a 26-week randomized, controlled trial. Eur J Endocrinol. 2018;178:491-499. (Among 92 adults with growth hormone deficiency on once daily growth hormone therapy who were randomized to receive weekly injections of somapacitan vs daily norditropin for 26 weeks, IGF-1 levels were maintained in the normal range with both agents, adverse events rates were similar, and there were “no clinically relevant changes…in clinical laboratory measurements”). 29500310
Sävendahl L, Battelino T, Brod M, Højby Rasmussen M, Horikawa R, Juul RV, Saenger P; REAL 3 study group. Once-weekly somapacitan vs daily GH in children with GH deficiency: results from a randomized phase 2 trial. J Clin Endocrinol Metab. 2020;105:e1847–61. (Among 59 previously untreated, pre-pubertal children with growth hormone deficiency treated with one of 3 doses of once weekly somapacitan or daily growth hormone, height velocity was greater with the highest dose of somapacitan [12.9 vs 11.4 cm per year], while adverse event rates were similar and there were “no clinically relevant findings” in laboratory measurements). 31917835
Johannsson G, Gordon MB, Højby Rasmussen M, Håkonsson IH, Karges W, Sværke C, Tahara S, et al. Once-weekly somapacitan is effective and well tolerated in adults with GH deficiency: a randomized phase 3 trial. J Clin Endocrinol Metab. 2020;105:e1358–76. (Among 301 adults with growth hormone deficiency treated with somapacitan weekly vs recombinant growth hormone daily vs placebo for 34 weeks, improvements in truncal fat percentage and IGF-1 levels were similar with both forms of growth hormone in comparison to placebo, and both total and serious adverse event rates were similar in the three groups and there were no hepatic severe adverse events; no mention of ALT elevations or hepatotoxicity). 32022863
Miller BS, Blair JC, Rasmussen MH, Maniatis A, Kildemoes RJ, Mori J, Polak M, et al. Weekly somapacitan is effective and well tolerated in children With GH deficiency: the randomized phase 3 REAL4 trial. J Clin Endocrinol Metab. 2022;107:3378-3388. (Among 200 children with prepubertal growth hormone deficiency treated with somapacitan or daily recombinant growth hormone [somatropin] for 52 weeks followed by open-label somapacitan for up to 4 years, the increase in height velocity was similar with both forms of growth hormone and adverse events were largely mild-to-moderate and considered unrelated to therapy; there were no discontinuations or deaths attributed to therapy; no mention of ALT levels or hepatotoxicity). 36062966
Sävendahl L, Battelino T, Højby Rasmussen M, Brod M, Röhrich S, Saenger P, Horikawa R. Weekly somapacitan in GH deficiency: 4-year efficacy, safety, and treatment/disease burden results from REAL 3. J Clin Endocrinol Metab. 2023;108:2569-2578. (Among 50 prepubertal children enrolled in a long term open-label safety evaluation study with 4 years of follow up, no new safety signals were identified and there were no treatment related serious adverse events; no mention of ALT elevations but one child was said to have nonalcoholic fatty liver disease). 36995872
Miller BS, Blair JC, Rasmussen MH, Maniatis A, Mori J, Böttcher V, Kim HS, et al. Effective GH replacement with somapacitan in children with GHD: REAL4 2-year results and after switch from daily GH. J Clin Endocrinol Metab. 2023;108:3090-3099. (Among 194 children with growth hormone deficiency treated with once weekly somapacitan or once daily growth hormone for one year followed by somapacitan in all patients for another year, height velocity improved and IGF-1 levels normalized in both groups and were maintained for 2 years, and while both therapies were well tolerated, once weekly somapacitan was preferred and there were no treatment related serious adverse events or discontinuations). 37406251

## OTHER REFERENCE LINKS

Recent References on Somapacitan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Somapacitan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Somapacitan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Somapacitan)

Sponsor: Novo Nordisk, Inc